# Ticarcillin

## OVERVIEW

### Introduction

Ticarcillin is an extended-spectrum carboxypenicillin antibiotic and is used to treat moderate-to-severe infections due to susceptible organisms. Ticarcillin has been linked with idiosyncratic liver injury, but only rarely and as isolated case reports.

### Background

Ticarcillin (tye" kar sil' in) is a fourth generation, extended-spectrum penicillin antibiotic which was previously used for moderate-to-severe infections caused by susceptible gram positive and gram negative agents. The extended spectrum of ticarcillin made it an appropriate agent in therapy of Pseudomonas aeruginosa. Ticarcillin also has extended activity against some Enterobacter and Proteus species. Ticarcillin has activity against most of the agents that are sensitive to natural penicillins, but is often less active. Ticarcillin is resistant to inactivation by many, but not all beta-lactamases. Ticarcillin was withdrawn from the market in the United States in 2004. Previously it was available in parenteral forms generically and under the name Ticar and is usually given in doses of 200 to 300 mg/kg per day in divided doses intravenously every 4 to 6 hours. Common side effects included nausea, diarrhea, dizziness, headache, rash and hypersensitivity reactions. Rare but potentially severe adverse events included severe hypersensitivity reactions, anaphylaxis and Stevens Johnson syndrome.

### Hepatotoxicity

Intravenous ticarcillin therapy has been associated with mild and transient serum aminotransferase elevations that were generally self-limited and only slightly more common with ticarcillin than with comparative antibiotics. Much more commonly reported were instances of anicteric hepatic injury from carbenicillin, a similar carboxypenicillin with extend coverage against Pseudomonas. Persons receiving high doses of intravenous carbenicillin not uncommonly (15% to 30%) developed serum aminotransferase elevations without jaundice, which promptly fell to normal with discontinuation or switching to another antibiotic. Recurrence is common with retreatment using carbenicillin, but not with ticarcillin. A similar phenomenon occurs with intravenous oxacillin. Rare instances of idiosyncratic, clinically apparent cholestatic liver injury have been reported in persons receiving ticarcillin in combination with clavulanate, some of which resemble the rare idiosyncratic reactions that can occur with many penicillins and which resemble the cholestatic liver injury that occurs after amoxicillin/clavulanate.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the idiosyncratic liver injury associated with ticarcillin use was probably hypersensitivity or allergy. No cases of rechallenge or reexposure have been reported.

### Outcome and Management

There have been too few cases of ticarcillin related liver injury to assess the prognosis and outcome. Patients with ticarcillin induced hepatitis should avoid reexposure to other penicillins and should take cephalosporins with caution.

References to the safety and potential hepatotoxicity of ticarcillin are provided in the drug record on Ticarcillin-Clavulanate.

Drug Class: Antiinfective Agents, Penicillins (Fourth Generation)

Other Drugs in the Class: Piperacillin, Piperacillin-Tazobactam, Ticarcillin-Clavulanate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ticarcillin – Generic, Ticar®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ticarcillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ticarcillin | 34787-01-4 | C15-H16-N2-O6-S2

## OTHER REFERENCE LINKS

1 Recent References on Ticarcillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ticarcillin)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ticarcillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ticarcillin)